# Psoriasis Agents

## OVERVIEW

### Introduction

Psoriasis is a chronic inflammatory skin disease that affects up to 2.5% of the United States population. Psoriasis varies greatly in severity, from an intermittent condition with a few localized patches of skin involvement, to a widespread serious skin disease with severe pruritus, extensive skin involvement, complications and disability. Psoriasis is associated with an inflammatory arthritis in at least 5% of cases. The typical psoriatic skin lesion is a raised, erythematous and sharply demarcated papule or plaque, often with a silvery crust. They are often pruritic. Histology shows acanthosis and inflammation with neutrophils and lymphocytes, which are rich in activated T cells. The etiology of psoriasis is not well defined, but it appears to be an autoimmune condition or a disease of immune dysregulation. The therapy of psoriasis ranges from topical ointments and oral therapies to intravenously or subcutaneously administered biologics. Milder cases can be managed by topical ointments, corticosteroids and vitamin D and retinoid derivatives. Systemic therapy is used for more severe disease or extensive skin involvement. Agents used include psoralen with ultraviolet light, methotrexate, acitretin, phosphodiesterase type 4 inhibitors (apremilast), cyclosporine or other immunomodulatory agents and, most recently, antitumor necrosis factor agents and monoclonal antibodies directed at activated T cells or their proinflammatory cytokines (secukinumab, ustekinumab). Psoriatic arthritis is typically treated similarly as rheumatoid arthritis.

Most of the agents used to treat severe psoriasis have other major uses, such as in cancer chemotherapy (methotrexate), organ transplantation (cyclosporine), and autoimmune diseases (antitumor necrosis factor agents, secukinumab, ustekinumab). Antipsoriatic medications that have been linked to cases of hepatotoxicity include methotrexate, acitretin and the tumor necrosis factor antagonists.

Antipsoriatic medications discussed in LiverTox include the following:

- Acitretin, Alefacept, Apremilast, Cyclosporine, Methotrexate, Psoralen (Methoxsalen)
- Monoclonal Antibodies
  - IL-17A Antagonists
    - Brodalumab, Ixekizumab, Secukinumab
  - Tumor Necrosis Factor Antagonists
    - Adalimumab, Certolizumab, Etanercept, Golimumab, Infliximab
  - Other
    - Deucravacitinib, Efalizumab, Guselkumab, Risankizumab, Tildrakizumab, Ustekinumab

## ANNOTATED BIBLIOGRAPHY

References updated: 10 July 2020

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Sewell MJ. Burkhart C, Morrell D. Dermatological pharmacology. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1271-96. (Textbook of pharmacology and therapeutics).
Drugs for psoriasis. Med Lett Drugs Ther 2015; 57(1470): 81-4. (Concise review and guidelines for use of drugs to treat psoriasis). 26035746
Drugs for psoriatic arthritis. Med Lett Drugs Ther 2015; 57(1470): e88-92. (Concise review and guidelines for use of drugs to treat psoriatic arthritis). 26035749
Drugs for psoriasis. Med Lett Drugs Ther 2019; 61(1574): 89-96. (Concise review and guidelines for use of drugs to treat psoriasis). 31381544
Drugs for psoriatic arthritis. Med Lett Drugs Ther 2019; 61(1588): 203-10. (Concise review and guidelines for use of drugs to treat psoriatic arthritis). 31999665